# Erdafitinib

## OVERVIEW

### Introduction

Erdafitinib is an oral small molecule inhibitor of fibroblast growth factor (FGF) receptors 1 to 4 that is used in the therapy of locally advanced, unresectable or metastatic urothelial carcinoma. Erdafitinib has been associated with a high rate of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent acute liver injury.

### Background

Erdafitinib (er” da fi’ ti nib) is an orally available, small molecule inhibitor of fibroblast growth factor (FGF) receptors 1-4 which is used to treat advanced, unresectable or metastatic urothelial carcinoma. Fibroblast growth factors include 22 related ligands that act on cells via more than 20 different FGF receptors which act on multiple pathways that include stimulation of cell growth, proliferation and differentiation. Mutations in FGF receptors can cause overexpression and constitutive activation of components of these pathways leading to unregulated cell proliferation. FGF receptor mutations or rearrangements occur in 5% to 10% of cancers and are particularly common in urothelial cancer and cholangiocarcinoma (10% to 30%). Inhibition of the excessive FGF receptor 1-4 activity decreases cell proliferation and growth and causes regression of tumors expressing these mutations in experimental animals. Erdafitinib is a pan-FGF receptor inhibitor and has been shown to lead to objective responses in approximately 40% of patients with advanced urothelial cancer that have FGF receptor activating mutations. Erdafitinib was approved for use in 2019 in the United States as therapy for patients with locally advanced, unresectable or metastatic urothelial carcinoma that harbor FGF receptor 3 or 2 mutations. Erdafitinib is currently being evaluated in several other cancers with FGF receptor mutations including cholangiocarcinoma, hepatocellular carcinoma, non-small cell lung cancer, esophageal carcinoma, prostate cancer, and lymphomas. Erdafitinib is available in tablets of 3, 4, and 5 mg under the brand name Balversa. The recommended dose is 8 mg once daily which can be increased to 9 mg daily. Side effects arise in almost all patients treated with erdafitinib and can include hyperphosphatemia, stomatitis, diarrhea, dry mouth, decreased appetite, dysgeusia, dry skin, alopecia, constipation, anemia, thrombocytopenia, elevations in serum creatinine, amylase, lipase, alkaline phosphatase, and aminotransferases. Uncommon, but potentially serious side effects include retinal detachment, cataracts, severe hyperphosphatemia, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of erdafitinib in patients with urothelial carcinoma, liver test abnormalities were frequent although usually mild. Some degree of ALT elevation arose in up to 41% of erdafitinib treated patients, but were above 5 times the upper limit of normal in only 1% to 2%. In these trials that enrolled approximately 400 patients, there were no reports of serious or clinically apparent liver injury, or liver related deaths. Since the approval and more wide spread use of erdafitinib there have been no reports of liver injury attributed to its use. Nevertheless, the high rate of serum aminotransferase elevations during therapy suggests that rare instances of clinically apparent liver injury might occur.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury from erdafitinib is unknown, but a pattern of abnormalities suggests some degree of low level, direct hepatotoxicity. Some of the adverse effects of erdafitinib are due to its effects on FGF signaling (hyperphosphatemia) and others may be due to off-target effects on other kinases. Erdafitinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 (and by CYP 2C9 to a lesser extent) and is susceptible to drug-drug interactions with agents that inhibit or induce CYP 3A enzyme reactivity.

### Outcome and Management

Erdafitinib is associated with a moderate rate of serum aminotransferase elevations that are generally transient and not associated with symptoms or jaundice. While regular monitoring of liver tests is not specifically recommended during erdafitinib therapy, elevations if confirmed should lead to more careful follow up monitoring. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation until the abnormalities resolve or an alternative cause is identified. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between erdafitinib and other protein kinases including the FGF receptor kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other FGF Receptor Kinase Inhibitors: Futibatinib, Infigratinib, Pemigatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Erdafitinib – Balversa®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Erdafitinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Erdafitinib | 1346242-81-6 | C25-H30-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 01 December 2022

Abbreviations: FGF, fibroblast growth factor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss erdafitinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212018Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial clinical review of the safety and efficacy of erdafitinib; states that virtually all patients had at least one adverse event and that serious adverse events arose in 67 of 164 patients [41%],most commonly hyperphosphatemia [82%], stomatitis [56%], creatinine elevations [49%], dry mouth [46%], alkaline phosphatase elevations [44%], diarrhea [42%), and ALT elevations [42%, which were above 5 times ULN in 2%], but there were no instances of aminotransferase elevations with jaundice).
Arai Y, Totoki Y, Hosoda F, Shirota T, Hama N, Nakamura H, Ojima H, et al. (2014). Fibroblast growth factor receptor tyrosine kinase fusions define a unique molecular subtype of cholangiocarcinoma. Hepatology. (Whole transcriptome sequencing from 8 cholangiocarcinomas identified two FGF receptor fusion genes and screening of different human cancer tissues found FGF receptor fusions in 9 of 102 cholangiocarcinomas [all intrahepatic] but only 1 of 149 colorectal, 1 of 96 hepatocellular, and none of 212 gastric cancers; expression of the fusion kinases in cell cultures led to anchorage independent growth and tumorigenesis when implanted in mice).
Karkera JD, Cardona GM, Bell K, Gaffney D, Portale JC, Santiago-Walker A, Moy CH, et al. (2017). Oncogenic characterization and pharmacologic Sensitivity of activating fibroblast growth factor receptor (FGFR) genetic alterations to the selective FGFR inhibitor erdafitinib. Mol Cancer Ther. (Analysis of cancer cell lines and tumor tissue from patients found that gene alterations in FGF receptors [translocations, gene amplification, point mutations] were associated with increased pathway activation and with responsivity to erdafitinib inhibition, suggesting that the FGF pathway would be a potential target for inhibition).
Markham A. (2019). Erdafitinib: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of erdafitinib shortly after its approval for use in the US as therapy of urothelial carcinoma with FGF receptor 2 or 3 mutations that adverse events occur in most patients and severe events arise in 41% of patients and account for discontinuation in 13% and drug interruptions in 68% of recipients; mentions but does not specifically discussion ALT elevations).
Loriot Y, Necchi A, Park SH, Garcia-Donas J, Huddart R, Burgess E, Fleming M, et al., BLC2001 Study Group. (2019). Erdafitinib in locally advanced or metastatic urothelial carcinoma. N Engl J Med. (Among 99 patients with advanced or metastatic urothelial carcinoma enrolled in an open label trial of erdafitinib [8 mg daily], the confirmed response rate was 40% [complete 3%], and the progression free survival 6.5 months, while adverse events occurred in all patients and included hyperphosphatemia [77%], stomatitis [58%], diarrhea [51%], dry mouth [46%], decreased appetite [37%], dry skin [32%], alopecia [29%], constipation [28%], asthenia [20%], ALT elevations [17%, 2% above 5 times ULN], but there was no clinically apparent liver injury with jaundice).
Schlotman A, Stater A, Schuler K, Heideman J, Abramson V. (2020). Grade 3 hepatotoxicity following fulvestrant, palbociclib, and erdafitinib therapy in a patient with ER-positive/PR-negative/HER2-negative metastatic breast cancer: a case report. Case Rep Oncol. (49 year old woman with breast cancer developed fatigue after 2 days of combination chemotherapy with erdafitinib, palbociclib and fulvestrant followed by diarrhea and abdominal pain, and laboratory tests at week one showed [ALT 522 U/L, Alk P 281 U/L, bilirubin 0.9 mg/dL] that rapidly fell to normal upon stopping all 3 agents).
Krook MA, Reeser JW, Ernst G, Barker H, Wilberding M, Li G, Chen HZ, et al. (2021). Fibroblast growth factor receptors in cancer: genetic alterations, diagnostics, therapeutic targets and mechanisms of resistance. Br J Cancer. (Review of the FGF receptors and their gene alterations in cancers including translocations, rearrangements, fusions, increase in copy numbers, and point mutations which are found in 5-10% of cancers, most frequently in urothelial cancers and cholangiocarcinoma [10-30%]; targeted therapy using inhibitors of FGF receptors has been limited by the development of resistance in many patients).

## OTHER REFERENCE LINKS

1 Recent References on Erdafitinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Erdafitinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Erdafitinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Erdafitinib)